# Colesevelam

## OVERVIEW

### Introduction

Colesevelam is a nonabsorbed bile acid sequestrant that is used a therapy of hyperlipidemia and for the pruritus of chronic liver disease and biliary obstruction. Colesevelam has not been associated with clinically apparent liver injury.

### Background

Colesevelam (koe" le sev' e lam) is a large, highly positively charged anion exchange resin that binds to negatively charged anions such as bile acids (as well as other organic compounds and some medications). The binding of bile acids to colesevelam creates an insoluble compound that cannot be reabsorbed and is thus excreted in the feces. Bile acids ordinarily undergo extensive (>95%) enterohepatic recirculation, being secreted in bile, acting as fat solubilizing compounds in the upper intestine, and then being reabsorbed in the distal small bowel. Chronic loss of bile acids results in a contraction in the total bile acid pool. The liver compensates for this decrease by increasing bile acid synthesis, which directly competes with cholesterol synthesis resulting in a decrease in serum levels. Some of the decrease in serum cholesterol may also result from inhibition of fat absorption by the binding of bile acids to colesevelam. Colesevelam was approved for use in the United States in 2000 and is currently used largely as an adjunctive therapy when statins or other lipid lowering agents result in an inadequate decrease in cholesterol levels. Colesevelam is also approved as an adjunct to diet and exercise to improve glycemic control in type 2 diabetes. Colesevelam is available in tablets of 625 mg under the brand name of Welchol. The usual dose is three tablets twice a day, given with meals or six tablets once daily. Other drugs should be given 1 hour before or 4 to 6 hours after colesevelam. Colesevelam is administered in tablet form and does not have the problem of lack of palatability that is characteristic of other bile acid resins. Side effects include abdominal discomfort, indigestion, nausea, flatuence and constipation.

### Hepatotoxicity

There is little evidence that colesevelam causes significant liver injury. Mild elevations in serum aminotransferase and alkaline phosphatase levels have been reported in small numbers of patients on bile acid resins, but the elevations have been mild, transient and without accompanying symptoms. Colesevelam is used in patients with liver disease to treat pruritus, and has little or no effect on serum enzyme or bilirubin levels.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The lack of hepatic injury by colesevelam is probably due to the fact that it is not absorbed, and the contraction of the bile acid pool caused by its use does not harm the liver. Because colesevelam can interfere with the absorption of other medications or vitamins, it may indirectly exacerbate liver disease by lowering effective levels of medications used for liver disease. These effects are particularly important for vitamins A, D, E, K, hormones such as estrogens, corticosteroids, and thyroid hormone, and medications such as thiazide diuretics, acetaminophen and digoxin.

References on the safety and hepatotoxicity of colesevelam are given with those for cholestyramine and colestipol in the Overview section on Bile Acid Resins/Sequestrants.

Drug Class: Antilipemic Agents, Bile Acid Resins/Sequestrants

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Colesevelam – Welchol®

DRUG CLASS

Antilipemic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=colesevelam)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Colesevelam | 182815-43-6 | Unspecified | No Image

## OTHER REFERENCE LINKS

1. Recent References on Colesevelam: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=colesevelam+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Colesevelam: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=colesevelam)